# Lumateperone

## OVERVIEW

### Introduction

Lumateperone is a second generation (atypical) antipsychotic agent that is used in the treatment of schizophrenia. Lumateperone is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Lumateperone (loo” ma te’ per one) is a second generation antipsychotic agent which appears to act as a serotonin (5-HT)-2A receptor and dopamine type 2 (D2) antagonist and is similar in structure and mechanism of action to paliperidone. It has low affinity for histamine-1 and alpha adrenergic-1 receptors and also is a partial serotonin reuptake inhibitor. Several randomized controlled trials have shown that oral lumateperone improves symptoms of schizophrenia and is comparable in effect to risperidone, but may be better tolerated. Lumateperone was approved for use in the United States in 2019 as treatment of adults with schizophrenia. Indications were subsequently extended to include depressive episodes in patients with bipolar I or II disorders including use as an adjunctive therapy with lithium or valproate. Lumateperone is available as capsules of 10.5, 21 and 42 mg under the brand name Caplyta. The recommended dosage in adults is 42 mg once daily. Common side effects include somnolence, fatigue, nausea, dizziness, dry mouth, nasal congestion, anxiety, restlessness and weight gain. Potential but rare severe adverse reactions (mentioned in most antipsychotic and antidepressant product labels) include excess mortality and cerebral vascular accidents in elderly patients with dementia, suicidal thoughts and behaviors, tardive dyskinesia, major neurologic events, neuroleptic malignant syndrome, orthostatic hypotension, seizures and neutropenia.

### Hepatotoxicity

In preregistration controlled trials, ALT elevations arose in 2% of patients receiving lumateperone compared to less than 1% of placebo controls. The elevations, however, were usually mild, transient and typically resolved without dose modification or drug discontinuation. In preregistration trials, there were no instances of severe hepatic adverse events, discontinuations because of liver related events or episodes of clinically apparent liver injury with jaundice. Since its approval and more widescale use, there have been no published reports of liver injury with symptoms or jaundice attributed to lumateperone therapy, but clinical experience with its use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lumateperone might cause serum ALT elevations or liver injury is not known. Lumateperone is metabolized in the liver by multiple enzymes include CYP 3A4, 2C8 and 1A2 and drug-drug interactions may occur with agents that are strong inhibitors or inducers of hepatic microsomal enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur on lumateperone therapy are usually self-limited and often do not require dose modification or discontinuation. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to lumateperone. Cross sensitivity to liver related or other hypersensitivity reactions between lumateperone and structurally related antipsychotic agents (such as paliperidone, iloperidone, lurasidone, risperidone and ziprasidone) have not been demonstrated, but may well occur.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lumateperone – Caplyta®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lumateperone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lumateperone | 313368-91-1 | C24-H28-F-N3-O
Paliperidone | 144598-75-4 | C23-H27-F-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: June 6, 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/209500Orig1s000MultidisciplineR.pdf (FDA website with product labels and the multidispline review of lumateperone that supported its approval for use in schizophrenia mentions ALT elevations arose in 2% of patients taking lumateperone vs 1% of controls and that 6 of 595 patients in one study developed ALT elevations above 3 times ULN during therapy, but all were less than 5 times ULN and most were self-limited and none were accompanied by jaundice).
Correll CU, Davis RE, Weingart M, Saillard J, O'Gorman C, Kane JM, Lieberman JA, et al. (2020). Efficacy and safety of lumateperone for treatment of schizophrenia: a randomized clinical trial. JAMA Psychiatry. (Among 450 adults with an acute exacerbation of schizophrenia treated with lumateperone [28 or 42 mg] or placebo once daily for 28 days, symptomatic response rates were higher with lumateperone [36% and 37% than placebo 26%] as were adverse event rates [57% and 65% vs 50%] including somnolence, sedation, fatigue and constipation; no mention of ALT elevations or hepatotoxicity).
(2020). Lumateperone (Caplyta) for schizophrenia. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of lumateperone shortly after its approval for use in the US mentions common side effects of somnolence, nausea, dry mouth and elevations in serum aminotransferases).
Greenwood J, Acharya RB, Marcellus V, Rey JA. (2021). Lumateperone: a novel antipsychotic for schizophrenia. Ann Pharmacother. (Review of the mechanism of action, clinical efficacy and safety of lumateperone mentions that it has high affinity for the serotonin 2A receptor, moderate affinity for dopamine 1 receptor, and may also act as a serotonin-reupdate inhibitor; in two short term clinical trials, lumateperone improved both negative and positive symptoms of schizophrenia, but long term results with comparisons to other second generation antipsychotics have not been reported).
Correll CU, Vanover KE, Davis RE, Chen R, Satlin A, Mates S. (2021). Safety and tolerability of lumateperone 42 mg: an open-label antipsychotic switch study in outpatients with stable schizophrenia. Schizophr Res. (Among 301 adults with stable schizophrenia who were switched from another atypical antipsychotic to lumateperone for 6 weeks, symptom scores were stable while 31% developed a drug related adverse event which were mostly mild-to-moderate somnolence [7%], headache [5%] and dry mouth [5%], and among the severe adverse events [3%], none were liver related; no mention of ALT elevations).
D'Souza I, Durgam S, Satlin A, Davis RE, Kozauer SG, Chen R, Mates S, et al. (2021). Lumateperone (ITI-007) in the treatment of bipolar depression: results from a randomized clinical trial. CNS Spectrums. (Abstract only: among 377 adults with bipolar disorders experiencing a manic episode treated with lumateperone [42 mg] vs placebo daily for 6 weeks, remission rates were 51% vs 37% at day 43, and therapy was “generally well tolerated”; no information on ALT levels or hepatotoxicity).
Kane JM, Durgam S, Satlin A, Vanover KE, Chen R, Davis R, Mates S. (2021). Safety and tolerability of lumateperone for the treatment of schizophrenia: a pooled analysis of late-phase placebo- and active-controlled clinical trials. Int Clin Psychopharmacol. (Pooled results from 3 randomized, double-blind controlled trials of lumateperone [n=406] vs risperidone [n=255] and placebo [n=411] for 4 or 6 weeks, overall adverse event rates were 66%, 69% and 55% and there were no deaths and no liver related discontinuations or serious adverse events, and while there were minor average increases in ALT, AST and Alk P on lumateperone therapy, there were no instances of liver injury with jaundice).
Calabrese JR, Durgam S, Satlin A, Vanover KE, Davis RE, Chen R, Kozauer SG, et al. (2021). Efficacy and safety of lumateperone for major depressive episodes associated with bipolar I or bipolar II disorder: a phase 3 randomized placebo-controlled trial. Am J Psychiatry. (Among 377 adults with bipolar disorders experiencing a major depressive episode enrolled in a randomized controlled trial for 6 weeks, symptom scores improved more with lumateperone [42 mg daily] than placebo and adverse events arose in 55% vs 50%, but there were no serious hepatic adverse events; no mention of ALT elevations or hepatotoxicity).
(2022). Lumateperone (Caplyta) for bipolar depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and cost of lumateperone shortly after its approval in the US for treatment of bipolar depression; does not mention ALT elevations or hepatotoxicity).
Suppes T, Durgam S, Kozauer SG, Chen R, Lakkis HD, Davis RE, Satlin A, et al. (2023). Adjunctive lumateperone (ITI-007) in the treatment of bipolar depression: Results from a randomized placebo-controlled clinical trial. Bipolar Disord. (Among 529 adults with bipolar I and II disorder on valproate or lithium to which was added lumateperone [28 or 42 mg] or placebo once daily for 6 weeks, depression symptom scores improved more with lumateperone than placebo [-16.2 and -16.9 vs -14.5], while total adverse event rates were similar and side effects more frequent with lumateperone included somnolence, dizziness and nausea; no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Lumateperone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lumateperone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lumateperone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lumateperone)